# Vitamin K

## OVERVIEW

### Introduction

Vitamin K is an essential fat soluble vitamin that is important in maintaining normal coagulation, serving as a cofactor in the activation of several clotting factors and anticoagulant proteins. There is no evidence that vitamin K supplementation, in physiologic or even higher doses, causes serum enzyme elevations, liver injury or jaundice.

### Background

Vitamin K is a fat soluble vitamin that exists in two natural forms: phytonadione (K1: fye toe" na dye' one) which is derived from plant sources and menadione (K2: men" a dye’ one) which is derived from bacterial sources. Vitamin K is a cofactor in the photosynthetic electron-transport system in green plants, which are the major dietary source of vitamin K for humans. High levels of vitamin K1 are found in leafy green vegetables while vitamin K2 is found in meat, milk and butter. In humans, vitamin K is an essential cofactor in the gamma-carboxylation of glutamate residues of several clotting factors and anticoagulant proteins. The gamma-carboxylation activates these factors and allows for their interactions with calcium and membrane phospholipids, essential for the coagulation cascade. Dietary deficiency of vitamin K is rare; the usual causes of deficiency being malabsorption or pharmacologic inhibition. The body stores of vitamin K are not high and its absorption is highly dependent upon bile. For these reasons, patients with cholestatic liver disease, cirrhosis and small bowel malabsorption may develop vitamin K deficiency. In addition, warfarin and other coumadin derivatives are potent anticoagulants that act by blocking vitamin K-dependent gamma-carboxylation of clotting factors. High doses of vitamin K can reverse these effects. Vitamin K is also used to treat hemorrhagic disease of the newborn, although the role of vitamin K in this syndrome is not completely clear. Finally, vitamin K may also play a role in prevention of osteoporosis, although its efficacy in restoring bone density has not been shown. The human requirement for vitamin K has not been defined precisely, but the recommended daily adequate intake for adults is 120 µg for men and 90 µg for women. Vitamin K is available over-the-counter in multiple forms, including tablets, capsules and oral solutions and is also found in many multivitamin preparations (in typical concentrations of 30 to 80 µg). Parenteral formulations are available by prescription and are used to treat severe vitamin K deficiency particularly in the face of active bleeding, either as phytonadione (also known as phylloquinone) or menadione (also known as menaquinone) generically or under brand names including Aquamephyton, Konakion and Mephyton. Vitamin K is also given routinely to newborns to treat or prevent hemorrhagic disease of the newborn. The parenteral formulations should be given subcutaneously as intravenous administration has been associated with anaphylactic-like reactions.

### Hepatotoxicity

Neither normal nor excessively high doses of vitamin K have associated with adverse events, ALT elevations or clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

It is not clear how vitamin K might cause liver injury. Vitamin K is taken up and stored in the liver, but does not undergo metabolism by the liver cytochrome P450 system.

Drug Class: Vitamins

Other Drugs in the Class: Vitamin A, Vitamin B, Vitamin C, Vitamin D, Vitamin E, Folate, Niacin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vitamin K – Generic, Aquamephyton®

DRUG CLASS

Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vitamin+K)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Phytonadione | 84-80-0 | C31-H46-O2
Menadione | 58-27-5 | C11-H8-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 27 May 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; does not discuss vitamin K as a hepatotoxin).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp, 631-57. (Review of hepatotoxicity of dietary supplements, does not discuss vitamins and minerals).
Hogg K, Weitz JI. Blood coagulation and anticoagulation, fibrinolytic and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 585-604. (Textbook of pharmacology and therapeutics).
Olson RE. Vitamin K. In, Shils ME, Olson JA, Shike M, Ross AC, eds. Modern nutrition in health and disease. 9th ed. Baltimore: Williams & Wilkins, 1998; pp 363-80. (Textbook of nutrition).
Food and Nutrition Board, Institute of Medicine. DRI dietary reference intakes for vitamin A, vitamin K, arsenic, boron, iron, manganese, molybdenum, nickel, silicon, vanadium, and zinc. Washington DC: National Academy Press, 1998. (Reports from the Food and Nutrition Board of the Institute of Medicine on reference values for vitamin intake, replacing the previously published Recommended Dietary Allowances).
Office of Dietary Supplements. https://ods.od.nih.gov/factsheets/list-all/VitaminK/. (Fact sheet on vitamin K maintained and regularly updated by the Office of Dietary Supplements, National Institutes of Health).
Shearer MJ, Vitamin K. (1995). Lancet. (Review of the structure, mechanism of action, dietary sources, pharmacokinetics, metabolism and uses of vitamin K; no discussion of adverse events or mention of hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 7 cases due to niacin, but none were attributed to other vitamins such as vitamin K).
Booth SL. (2012). Vitamin K: food composition and dietary intakes. Food Nutr Res. (Summary of the dietary sources of vitamin K, average intakes and differences in absorption and utilization of different vitamin K molecules).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 were attributed to niacin, but none were attributed to any other vitamin including vitamin K).

## OTHER REFERENCE LINKS

1 Recent References on Vitamin K: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vitamin%20K/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Vitamin K: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vitamin%20K)